# Alzheimer Disease Agents

## OVERVIEW

Alzheimer disease is a progressive degenerative brain condition that is the most common cause of dementia worldwide. Alzheimer disease affects at least 5 million persons in the United States, including approximately 1% of individuals in their 60’s and up to 8% of those above the age of 85 years. The usual presentation is insidious with impaired memory and cognition and change in personality. The course is generally progressive with eventual mental and physical disability and death due to complications of immobility. The cause of Alzheimer disease is not known, but it is characterized by marked atrophy of the cerebral cortex and loss of neurons. Histologically, Alzheimer disease is marked by senile plaques, spherical accumulations of β-amyloid, degenerating neuronal processes and neurofibrillary tangles. Functionally, there appears to be impairment of cholinergic transmission. The increasing prevalence of Alzheimer disease in the elderly population has led to an increasing appreciation of the importance and the medical and social burden of Alzheimer disease. Early detection has led to attempts at therapy, the major goal being amelioration or slowing of its progressive course. Several medications have been found to alleviate some of the symptoms and signs of Alzheimer disease, but none have been proven to affect its ultimate course and outcome.

The pharmacotherapy of Alzheimer disease has focused on increasing cholinergic function in the brain. Acetylcholine precursors, such as choline and lecithin, have not proven beneficial, but inhibition of acetylcholine metabolism using inhibitors of acetylcholinesterase has been found to be partially successful in improving symptoms of Alzheimer disease. Four acetylcholinesterase inhibitors have been approved for use for Alzheimer disease in the United States: tacrine (Cognex: 1993), donepezil (Aricept: 1996), galantamine (Razadyne: 2001), and rivastigmine (Exelon: 2002). An alternative approach to treatment of Alzheimer disease is inhibition of N-methyl-D-aspartate (NMDA) glutamate receptors which is thought to lead to less excitotoxic injury to the brain. A single NMDA receptor inhibitor has been approved for use in Alzheimer disease in the United States: memantine (Namenda: 2003).

Therapy with tacrine has been associated with a very high rate of serum enzyme elevations, which can be dramatic although usually not associated with symptoms, jaundice or clinically apparent liver injury. Nevertheless, because of this side effect and the availability of other better tolerated cholinesterase inhibitors, tacrine is now no longer used. Except for tacrine, the drugs used for Alzheimer disease are rare causes of acute liver injury and have a low rate of associated serum enzyme elevations. The references on hepatotoxicity of the drugs used are listed together immediately after this introductory section. The agents referenced and discussed here include:

- Aducanumab
- Donanemab
- Donepezil
- Galantamine
- Lecanemab
- Memantine
- Rivastigmine
- Tacrine

Increasing efforts in Alzheimer disease research have sought to identify means of preventing or slowing the progression of disease. Most attention has been focused on preventing or decreasing brain accumulation of amyloid-β oligomers and soluble aggregates that are believed to be the cause of neuronal damage in Alzheimer disease. However, clinical trials of monoclonal antibodies to amyloid-β (bapineuzumab, solanezumab) and small molecule inhibitors of β-secretase, the rate-limiting enzyme of amyloid-β production (verubecestat, atabecestat, lanabecestat, elenbecestat) have failed to show benefit in early or late Alzheimer disease. Indeed, some of these agents were associated with worsening of symptoms and signs of Alzheimer disease, others were withdrawn for further evaluation because of suspected hepatotoxicity (atabecestat). These agents are not in current use and are not discussed individually in LiverTox. Selected references on these agents are given in the Annotated Bibliography below.

## ANNOTATED BIBLIOGRAPHY

References updated: 03 February 2020

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 709-42. (Expert review of hepatotoxicity published in 1999; tacrine, the first cholinesterase inhibitor approved for use in Alzheimer disease, was associated with a very high rate of serum ALT elevations [~50%], but rarely caused clinically apparent liver injury; the other Alzheimer disease agents are not discussed).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 518. (Review of hepatotoxicity of psychotropic agents; drugs for Alzheimer disease are not specifically discussed).
Roberson ED. Alzheimer's disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 333-5. (Textbook of pharmacology and therapeutics).
Chatellier G, Lacomblez L. Tacrine (tetrahydroaminoacridine; THA) and lecithin in senile dementia of the Alzheimer type: a multicentre trial. Groupe Françs d'Etude de la Tetrahydroaminoacridine. BMJ 1990; 300: 495-9. (In a randomized controlled crossover trial of tacrine in 67 patients with Alzheimer disease, 9 patients [13%] developed significant ALT or AST elevations, usually arising after 2-8 weeks of therapy, ALT 85-2115 U/L, one patient developed jaundice which resolved within 3-4 weeks of stopping). 2107926
Ames DJ, Bhathal PS, Davies BM, Fraser JR, Gibson PR, Roberts S. Heterogeneity of adverse hepatic reactions to tetrahydroaminoacridine. Aust N Z J Med 1990; 20: 193-5. (5 of 14 patients [36%] taking tacrine for Alzheimer disease developed abnormal liver tests [ALT 106-422 U/L, GTT 20-71 U/L, bilirubin normal], one was symptomatic; liver biopsies showed focal necrosis, fat and one patient with granulomas, all resolved with stopping the drug or lowering the dose). 2344330
Hammel P, Larrey D, Bernuau J, Kalafat M, Fréaux E, Babany G, Degott C, et al. Acute hepatitis after tetrahydroaminoacridine administration for Alzheimer's disease. J Clin Gastroenterol 1990; 12: 329-31. (A 76 year old woman with Alzheimer disease developed fever and jaundice 20 days after starting tacrine [bilirubin 5.0 mg/dL, ALT ~1800 U/L, Alk P 125 U/L, prothrombin index 40%], with rapid resolution on stopping, all liver tests falling to normal within 6 weeks). 2362104
O'Brien JT, Eagger S, Levy R. Effects of tetrahydroaminoacridine on liver function in patients with Alzheimer's disease. Age Ageing 1991; 20: 129-31. (Prospective analysis of liver tests in 30 patients with Alzheimer disease treated with tacrine; 50% developed AST elevations within 17-38 days, 8 had clinical symptoms but none had jaundice, all resolved within 3-23 days after stopping or dose reduction; 6 were restarted and 5 tolerated therapy long term). 2053502
Farlow M, Gracon SI, Hershey LA, Lewis KW, Sadowsky CH, Dolan-Ureno J. A controlled trial of tacrine in Alzheimer's disease. The Tacrine Study Group. JAMA 1992; 268: 2523-9. (Among 468 patients with Alzheimer disease treated with tacrine or placebo, ALT elevations [>3 times ULN] occurred in 25% of tacrine treated, but in none of placebo treated patients; all elevations were reversible and asymptomatic, usually arising in the first 8 weeks of treatment and resolving within 7-71 days of stopping). 1404819
Knapp MJ, Knopman DS, Solomon PR, Pendlebury WW, Davis CS, Gracon SI. A 30-week randomized controlled trial of high-dose tacrine in patients with Alzheimer's disease. The Tacrine Study Group. JAMA 1994; 271: 985-91. (In a randomized controlled trial of tacrine vs placebo in 653 patients with Alzheimer disease, some degree of ALT elevation occurred in 54% and elevations >3 times ULN in 28% of tacrine-treated patients, but no patient had jaundice and most were asymptomatic, all resolved on stopping tacrine). 8139083
Watkins PB, Zimmerman HJ, Knapp MJ, Gracon SI, Lewis KW. Hepatotoxic effects of tacrine administration in patients with Alzheimer's disease. JAMA 1994; 271: 992-8. (In depth analysis of liver test abnormalities occurring in 2446 patients on tacrine in multi-center trials; ALT elevations occurred in 49%, were >3 times ULN in 25%, >10 times ULN 6%, and >20 times ULN in 2%; usually arising within 6-8 weeks of starting, with no symptoms or minimal nausea and fatigue even when ALT >10 times ULN, eosinophilia in 23-44% but no rash, more rapid but less severe recurrence on rechallenge, nevertheless 88% could continue tacrine; more common in women than men). 8139084
Fulton B, Benfield P. Galanthamine. Drugs Aging 1996; 9: 60-5. (Review of pharmacology, efficacy and safety of galantamine in Alzheimer disease; most side effects were due to its cholinergic properties, including nausea, vomiting, abdominal pain, diarrhea, anxiety and dizziness; "to date, elevations in liver enzymes or other signs of liver toxicity have not been reported with galanthamine"). 8818586
Gracon SI, Knapp MJ, Berghoff WG, Pierce M, DeJong R, Lobbestael SJ, Symons J, et al. Safety of tacrine: clinical trials, treatment IND, and postmarketing experience. Alzheimer Dis Assoc Disord 1998; 12: 93-101. (Review of safety including hepatotoxicity of tacrine based upon registration trials and postmarketing adverse event reporting; ALT levels rise to >3 times the ULN in at least 25% of patients, but are usually asymptomatic and not associated with jaundice). 9651138
Rösler M, Anand R, Cicin-Sain A, Gauthier S, Agid Y, Dal-Bianco P, Stälin HB, et al. Efficacy and safety of rivastigmine in patients with Alzheimer's disease: international randomised controlled trial. BMJ 1999; 318: 633-8. (Controlled trial of two doses of rivastigmine vs placebo for 26 weeks in 725 patients with Alzheimer disease, no differences in ALT elevations between treatment and placebo arms; side effects included nausea, dizziness, headache, anorexia, fatigue and abdominal pain). 10066203
Wilcock GK, Lilienfeld S, Gaens E. Efficacy and safety of galantamine in patients with mild to moderate Alzheimer's disease: multicentre randomized controlled trial. Galantamine International-1 Study Group. BMJ 2000; 321: 1445-9. (Controlled trial of 6 months of two doses of galantamine vs placebo in 653 patients with Alzheimer disease: side effects included nausea, diarrhea, headache, anorexia and weight loss, but there were "no consistent trends or clinically important differences" in blood chemistry results). 11110737
Barbare JC, Imbert A, Benkirane A. [Recent developments concerning drug-induced liver toxicity]. Presse Med 2001; 30: 673-6. French. (Review of importance of central reporting of drug induced liver injury, providing examples of recently described hepatotoxic reactions, including 3 recent cases of hepatocellular injury due to riluzole). 11360729
Verrico MM, Nace DA, Towers AL. Fulminant chemical hepatitis probably associated with donepezil and sertraline therapy. J Amer Geriat Soc 2000; 48: 1659-63. (83 year old woman developed jaundice 10 days after starting donepezil and 5 months after starting sertraline [bilirubin 5.6 rising to 22.6 mg/dL, ALT 529 U/L, Alk P 369 U/L, peak INR 1.8], resolving after stopping both in the next 4 months). 11129758
Reisberg B, Doody R, Stöer A, Schmitt F, Ferris S, Mös HJ; Memantine Study Group. Memantine in moderate-to-severe Alzheimer's disease. N Engl J Med 2003; 348: 1333-41. (Controlled trial of 28 weeks of memantine vs placebo in 252 patients with Alzheimer disease: no differences in rates of any adverse event; serum ALT levels and hepatotoxicity not mentioned). 12672860
Pirttilä T, Wilcock G, Truyen L, Damaraju CV. Long-term efficacy and safety of galantamine in patients with mild-to-moderate Alzheimer's disease: multicenter trial. Eur J Neurol 2004; 11: 734-41. (Results of continuing galantamine for 24 months in 491 patients with Alzheimer disease; reported no instances of liver toxicity and "no clinically relevant trends" in "clinical laboratory parameters"). 15525294
Tariot PN, Farlow MR, Grossberg GT, Graham SM, McDonald S, Gergel I; Memantine Study Group. Memantine treatment in patients with moderate to severe Alzheimer disease already receiving donepezil: a randomized controlled trial. JAMA 2004; 291: 317-24. (Controlled trial of 24 weeks of memantine vs placebo in 404 patients with Alzheimer disease receiving donepezil: side effects that were more common with memantine were confusion and headache; "No clinically significant differences were detected between treatment groups...in laboratory tests"). 14734594
Seltzer B, Zolnouni P, Nunez M, Goldman R, Kumar D, Ieni J, Richardson S; Donepezil "402" Study Group. Efficacy of donepezil in early-stage Alzheimer disease: a randomized placebo-controlled trial. Arch Neurol 2004; 61: 1852-6. (Controlled trial of 24 weeks of donepezil vs placebo in 153 patients with early Alzheimer disease: side effects included diarrhea, nausea, fatigue, dizziness and insomnia; no mention of ALT elevations or hepatotoxicity). 15596605
Winblad B, Wimo A, Engedal K, Soininen H, Verhey F, Waldemar G, Wetterholm AL, et al. 3-year study of donepezil therapy in Alzheimer's disease: effects of early and continuous therapy. Dement Geriatr Cogn Disord 2006; 21: 353-63. (Continuation of donepezil for 3 years in 81 patients with Alzheimer disease reported no clinically significant changes in laboratory test results). 16508298
Winblad B, Kilander L, Eriksson S, Minthon L, Båman S, Wetterholm AL, Jansson-Blixt C, et al.; Severe Alzheimer's Disease Study Group. Donepezil in patients with severe Alzheimer's disease: double-blind, parallel-group, placebo-controlled study. Lancet 2006; 367: 1057-65. (Controlled trial of 6 months of donepezil vs placebo in 248 patients with severe Alzheimer disease; side effects were mostly mild and did not differ between donepezil and placebo treated patients; there were "no great changes in the results of laboratory tests"). 16581404
Bullock R. Efficacy and safety of memantine in moderate-to-severe Alzheimer disease: the evidence to date. Alzheimer Dis Assoc Disord 2006; 20: 23-9. (Review of the safety of memantine from 3 pivotal controlled trials and more than 100,000 patient-years of use: overall rates of side effects were not different from placebo, were mild-to-moderate, and often considered unrelated; no mention of hepatotoxicity). 16493232
Seltzer B. Donepezil: an update. Expert Opin Pharmacother 2007; 8: 1011-23. (Review of safety and efficacy of donepezil, the most commonly used agent in therapy of Alzheimer disease; no discussion of ALT elevations or hepatotoxicity). 17472546
Farlow MR, Cummings JL. Effective pharmacologic management of Alzheimer's disease. Am J Med 2007; 120: 388-97. (Review of safety and efficacy of medications for Alzheimer disease; no discussion of hepatotoxicity). 17466645
Bakchine S, Loft H. Memantine treatment in patients with mild to moderate Alzheimer's disease: results of a randomised, double-blind, placebo-controlled 6-month study. J Alzheimers Dis 2008; 13: 97-107. (Controlled trial of 24 weeks of memantine vs placebo in 470 patients with Alzheimer disease: adverse events occurred in similar rates with memantine and placebo, were all mild-to-moderate, and there "were no clinically meaningful differences between treatment groups" in laboratory tests). 18334761
Ferrara N, Corbi G, Capuano A, Filippelli A, Rossi F. Memantine-induced hepatitis with cholestasis in a very elderly patient. Ann Intern Med 2008; 148: 631-2. (92 year old woman developed jaundice and pruritus 16 days after starting memantine for dementia [bilirubin 4.3 mg/dL, ALT 132 U/L, Alk P 912 U/L], resolving within 3 weeks of stopping). 18413635
Dierckx RIR, Vandewoude MFJ. Donepezil-related toxic hepatitis. Acta Clin Belg 2008; 63: 339-42. (90 year old man with Alzheimer disease developed abdominal pain and jaundice 2 weeks after starting donepezil [bilirubin 5.9 rising to 22.6 mg/dL, ALT 329 U/L, Alk P 944 U/L], resolving over the next 3 months). 19186568
Hansen RA, Gartlehner G, Webb AP, Morgan LC, Moore CG, Jonas DE. Efficacy and safety of donepezil, galantamine, and rivastigmine for the treatment of Alzheimer's disease: a systematic review and meta-analysis. Clin Interv Aging 2008; 3: 211-25. (Systematic review of 3 cholinesterase inhibitors in Alzheimer disease; most common adverse events were nausea [19%], vomiting [13%], diarrhea [11%] and weight loss [9%] and withdrawal for adverse events in 11-21%; no mention of ALT elevations or hepatotoxicity). 18686744
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; none were attributed to a drug used to treat Alzheimer disease). 18955056
Mumoli N, Carmignani G, Luschi R, Cei M, Chiavistelli P. Hepatitis with cholestasis caused by rivastigmine transdermal patch. Am J Gastroenterol 2009; 104: 2859-60. (84 year old woman developed jaundice and rash 2 months after starting transdermal rivastigmine for Alzheimer disease [bilirubin 3.0 mg/dL, ALT 857 U/L, Alk P 344 U/L, eosinophils 8%], resolving within 5 weeks of stopping). 19888250
Mayeux R. Early Alzheimer's disease. N Engl J Med 2010; 362: 2194-201. (Case discussion and review of current understanding of Alzheimer disease including role of therapy; common side effects of cholinesterase inhibitors include nausea, vomiting, anorexia, diarrhea, dizziness, muscle cramps, insomnia and vivid dreams; memantine can cause constipation, dizziness, headache and body pains; no mention of hepatotoxicity). 20558370
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to drugs used to treat Alzheimer disease). 20949552
Farlow M, Veloso F, Moline M, Yardley J, Brand-Schieber E, Bibbiani F, Zou H, et al. Safety and tolerability of donepezil 23 mg in moderate to severe Alzheimer's disease. BMC Neurol 2011; 11: 57. (Among 1434 patients with Alzheimer disease treated with 10 vs 23 mg of donepezil daily for 24 weeks, cholinergic side effects were more common with the higher dose, but there were no differences in frequency of "clinically important" abnormal laboratory values). 21612646
Dubois B, Tolosa E, Katzenschlager R, Emre M, Lees AJ, Schumann G, Pourcher E, et al. Donepezil in Parkinson's disease dementia: a randomized, double-blind efficacy and safety study. Mov Disord 2012; 27: 1230-8. (Among 550 patients with Alzheimer disease treated with two doses of donepezil or placebo for 24 weeks, nausea, tremor, diarrhea, insomnia and anorexia were more frequent in patients on donepezil, but "Laboratory tests and physical examination data remained largely unchanged"). 22915447
Tariot P, Salloway S, Yardley J, Mackell J, Moline M. Long-term safety and tolerability of donepezil 23 mg in patients with moderate to severe Alzheimer's disease. BMC Res Notes 2012; 5: 283. (Among 915 patients with Alzheimer disease treated with donepezil in a dose of 23 vs 10 mg daily, cholinergic side effects were more common at the higher dose, but "there were no changes in laboratory test values"). 22681723
Tan CC, Yu JT, Wang HF, Tan MS, Meng XF, Wang C, Jiang T, et al. Efficacy and Safety of donepezil, galantamine, rivastigmine, and memantine for the treatment of Alzheimer's disease: a systematic review and meta-analysis. J Alzheimers Dis 2014; 41: 615-31. (Systematic review of safety and efficacy of 4 Alzheimer drugs does not mention ALT elevations or hepatotoxicity). 24662102
Tricco AC, Soobiah C, Berliner S, Ho JM, Ng CH, Ashoor HM, Chen MH, Hemmelgarn B, Straus SE. Efficacy and safety of cognitive enhancers for patients with mild cognitive impairment: a systematic review and meta-analysis. CMAJ. 2013 Nov 5; 185 (16): 1393-401. (Systematic review of 8 clinical trials and 3 reports on the safety and efficacy of Alzheimer drugs mentions that side effects of nausea, diarrhea, vomiting and headaches were usually more frequent with the active drugs compared to placebo; no mention of ALT elevations or clinically apparent liver injury). 24043661
Ikeda M, Mori E, Kosaka K, Iseki E, Hashimoto M, Matsukawa N, Matsuo K, Nakagawa M; Donepezil-DLB Study Investigators. Long-term safety and efficacy of donepezil in patients with dementia with Lewy bodies: results from a 52-week, open-label, multicenter extension study. Dement Geriatr Cogn Disord. 2013; 36 (3-4): 229-41. (Among 108 patients with dementia treated with donepezil for up to 52 weeks, no patient developed clinically apparent liver injury; 12 patients developed CPK elevations, but ALT elevations were not mentioned). 23949147
Salloway S, Mintzer J, Cummings JL, Geldmacher D, Sun Y, Yardley J, Mackell J. Subgroup analysis of US and non-US patients in a global study of high-dose donepezil (23 mg) in moderate and severe Alzheimer's disease. Am J Alzheimers Dis Other Demen 2012; 27: 421-32. (Reanalysis of safety and efficacy of a multinational trial of donepezil in Alzheimer disease found that rates of nausea, vomiting, anorexia, weight loss, fatigue and incontinence where twice as high in patients receiving higher doses of donepezil; no mention of ALT elevations or hepatotoxicity). 22930699
Gauthier S, Robillard A, Cohen S, Black S, Sampalis J, Colizza D, de Takacsy F, et al; EMBRACE investigators. Real-life effectiveness and tolerability of the rivastigmine transdermal patch in patients with mild-to-moderate Alzheimer's disease: the EMBRACE study. Curr Med Res Opin 2013; 29: 989-1000. (Among 969 Canadian patients with Alzheimer disease treated with rivastigmine patch for 18 months, 18% stopped treatment because of adverse events, usually skin reactions or nausea/vomiting; no mention of ALT elevations or clinically apparent liver injury). 23647369
Mäurer M, Ortler S, Baier M, Meergans M, Scherer P, Hofmann W, Tracik F. Randomised multicentre trial on safety and efficacy of rivastigmine in cognitively impaired multiple sclerosis patients. Mult Scler 2013; 19: 631-8. (Among 86 patients with multiple sclerosis and cognitive decline treated with rivastigmine or placebo patches for 16 weeks, side effects were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 23069874
Ikeda M, Mori E, Kosaka K, Iseki E, Hashimoto M, Matsukawa N, Matsuo K, Nakagawa M; Donepezil-DLB Study Investigators. Long-term safety and efficacy of donepezil in patients with dementia with Lewy bodies: results from a 52-week, open-label, multicenter extension study. Dement Geriatr Cogn Disord 2013; 36: 229-41. (Among 108 patients with dementia treated with open label donepezil for 52 weeks, there were no hepatic serious adverse events; no mention of ALT levels). 23949147
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the cases were attributed to a drug used to treat Alzheimer disease). 23419359
Hager K, Baseman AS, Nye JS, Brashear HR, Han J, Sano M, Davis B, Richards HM. Effects of galantamine in a 2-year, randomized, placebo-controlled study in Alzheimer's disease. Neuropsychiatr Dis Treat 2014; 10: 391-401. (Among 2045 patients with Alzheimer disease treated with galantamine or placebo for up to 2 years, symptoms of nausea, vomiting, and fatigue were slightly more frequent with galantamine than placebo, but serious adverse events were similar in the two groups and "No clinically meaningful changes were observed in... laboratory tests"). 24591834
Nakamura Y, Kitamura S, Homma A, Shiosakai K, Matsui D. Efficacy and safety of memantine in patients with moderate-to-severe Alzheimer's disease: results of a pooled analysis of two randomized, double-blind, placebo-controlled trials in Japan. Expert Opin Pharmacother 2014; 15: 913-25. (Among 633 Japanese patients with Alzheimer disease treated with either memantine or placebo, the rate of adverse events was similar in the two groups; no mention of ALT elevations or clinically apparent liver injury). 24673497
Dysken MW, Sano M, Asthana S, Vertrees JE, Pallaki M, Llorente M, Love S, et al. Effect of vitamin E and memantine on functional decline in Alzheimer disease: the TEAM-AD VA cooperative randomized trial. JAMA 2014; 311: 33-44. (Among 561 patients with Alzheimer disease treated with vitamin E, memantine, the combination or placebo for an average of 2.3 years, overall adverse events were similar in the 4 groups, but serious infections were more common with memantine than placebo (15% vs 7%); no mention of ALT elevations or hepatotoxicity). 24381967
Emre M, Poewe W, De Deyn PP, Barone P, Kulisevsky J, Pourcher E, van Laar T, et al. Long-term safety of rivastigmine in parkinson disease dementia: an open-label, randomized study. Clin Neuropharmacol 2014; 37 (1): 9-16. (Among 583 patients with Parkinson disease dementia treated with either rivastigmine capsules or patch, adverse events were more frequent with capsules, particularly tremor, nausea, vomiting, diarrhea and syncope; no mention of ALT elevations or hepatotoxicity). 24434526
Chew AP, Lim WS, Tan KT. Donepezil-induced hepatotoxicity in an elderly adult taking fluoxetine. J Am Geriatr Soc 2014; 62: 2009-11. (A 79 year old man with depression, Alzheimer disease and cirrhosis due to hepatitis was taking high doses of fluoxetine [80 mg daily] and lamivudine and developed fatigue and anorexia with abnormal liver tests 6 weeks after starting donepezil [bilirubin 1.5 mg/dL, ALT 177 U/L, Alk P 127 U/L], which resolved within 8 weeks of stopping both and did not recur on restarting sertraline along with and memantine instead of donepezil). 25333550
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a drug for Alzheimer disease). 24552865
Salloway S, Sperling R, Fox NC, Blennow K, Klunk W, Raskind M, Sabbagh M, et al.; Bapineuzumab 301 and 302 Clinical Trial Investigators. Two phase 3 trials of bapineuzumab in mild-to-moderate Alzheimer's disease. N Engl J Med 2014; 370: 322-33. (Among 2452 adults with mild-to-moderate Alzheimer disease treated in two controlled trials with bapineuzumab or placebo for 1.5 years, there was no improvement in symptoms of dementia, but amyloid-related imaging abnormalities arose in 4% to 15% of bapineuzumab treated subjects compared to 0.2% of placebo recipients). 24450891
Doody RS, Thomas RG, Farlow M, Iwatsubo T, Vellas B, Joffe S, Kieburtz K, et al. Alzheimer's Disease Cooperative Study Steering Committee; Solanezumab Study Group. Phase 3 trials of solanezumab for mild-to-moderate Alzheimer's disease. N Engl J Med 2014; 370: 311-21. (Among 2052 patients with mild-to-moderate Alzheimer disease treated in 2 trials with solanezumab or placebo for 18 months, there were no improvements in clinical symptoms with therapy compared to placebo and no differences in adverse event rates; no mention of ALT elevations or hepatotoxicity). 24450890
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to a drug for Alzheimer disease). 25754159
Kröger E, Mouls M, Wilchesky M, Berkers M, Carmichael PH, van Marum R, Souverein P, et al. Adverse drug reactions reported with cholinesterase inhibitors: an analysis of 16 years of individual case safety reports from VigiBase. Ann Pharmacother 2015; 49: 1197-206. (Analysis of spontaneous adverse event reports made between 2006 and 2013 to a WHO drug monitoring database identified 16,995 serious adverse events in patients receiving cholinesterase inhibitors, 121 of which were hepatobiliary, including 47 for donepezil, 53 rivastigmine and 21 galantamine; no details provided). 26324356
Ikeda M, Mori E, Matsuo K, Nakagawa M, Kosaka K. Donepezil for dementia with Lewy bodies: a randomized, placebo-controlled, confirmatory phase III trial. Alzheimers Res Ther 2015; 7: 4. (Among 142 patients with dementia with Lewy bodies treated with donepezil [5 or 10 mg] vs placebo for 12 weeks, adverse events were mild-to-moderate and those more frequent with donepezil were anorexia, nausea and Parkinson disease symptoms; no mention of ALT elevations or hepatotoxicity). 25713599
Wang HF, Yu JT, Tang SW, Jiang T, Tan CC, Meng XF, Wang C, et al. Efficacy and safety of cholinesterase inhibitors and memantine in cognitive impairment in Parkinson's disease, Parkinson's disease dementia, and dementia with Lewy bodies: systematic review with meta-analysis and trial sequential analysis. J Neurol Neurosurg Psychiatry 2015; 86: 135-43. (Systematic review of 10 trials of Alzheimer disease drugs in Parkinson disease and other forms of dementia reported that the common adverse events were cholinergic in nature [anorexia, nausea, diarrhea] and were generally mild-to-moderate in severity; serious adverse events were similar to rates with placebo; no mention of ALT elevations or hepatotoxicity). 24828899
Mohammad D, Chan P, Bradley J, Lanctôt K, Herrmann N. Acetylcholinesterase inhibitors for treating dementia symptoms - a safety evaluation. Expert Opin Drug Saf 2017; 16: 1009-19. (Review of safety of donepezil, galantamine and rivastigmine in Alzheimer disease concludes that adverse events are “generally mild”, mostly gastrointestinal, comparable among the different agents, but usually greater with higher doses and less with transdermal formulations). 28678552
Keskin AD, Kekuš M, Adelsberger H, Neumann U, Shimshek DR, Song B, Zott B, et al. BACE inhibition-dependent repair of Alzheimer's pathophysiology. Proc Natl Acad Sci U S A 2017; 114: 8631-6. (In a mouse model of Alzheimer disease, reduction in β-secretase activity decreased cerebral amyloid β proteins in the brain and improved measures of neuronal function). 28739891
Egan MF, Kost J, Tariot PN, Aisen PS, Cummings JL, Vellas B, Sur C, et al. Randomized trial of verubecestat for mild-to-moderate Alzheimer's disease. N Engl J Med 2018; 378: 1691-703. (Among 1958 patients with Alzheimer disease treated with verubecestat [12 or 40 mg] versus placebo daily for 18 months, symptoms of dementia did not improve, and adverse events were more frequent with active drug; there were no liver related severe adverse events). 29719179
Panza F, Lozupone M, Solfrizzi V, Sardone R, Piccininni C, Dibello V, Stallone R, et al. BACE inhibitors in clinical development for the treatment of Alzheimer's disease. Expert Rev Neurother 2018; 18: 847-57. (Review of the mechanism of action and results of clinical trials of β-site amyloid precursor protein cleaving enzyme [BACE] inhibitors [veru-, ata-, lana-, and elenbecestat] as therapy of Alzheimer disease mentions that most failed to show efficacy in human trials and that trials of atabecestat were discontinued because of serious serum enzyme elevations in some patients). 30277096
Timmers M, Streffer JR, Russu A, Tominaga Y, Shimizu H, Shiraishi A, Tatikola K, et al. Pharmacodynamics of atabecestat (JNJ-54861911), an oral BACE1 inhibitor in patients with early Alzheimer's disease: randomized, double-blind, placebo-controlled study. Alzheimers Res Ther 2018; 10: 85. (Among 33 patients with early Alzheimer disease treated with atabecestat [10 or 50 mg] or placebo once daily for 4 weeks, there were no changes in cognition and no “clinically significant trends in changes from baseline in …liver function tests”). 30134967
Yip LY, Aw CC, Lee SH, Hong YS, Ku HC, Xu WH, Chan JMX, et al. The liver-gut microbiota axis modulates hepatotoxicity of tacrine in the rat. Hepatology 2018; 67: 282-95. (In Lister hooded rats, tacrine administration resulted in variable increases in ALT and AST with higher levels correlating with higher systemic exposure, which could be modified by changing the intestinal bacterial flora [microbiome], which was likely the result of bacterial deglucuronidation of tacrine during enterohepatic recycling). 28646502
Dou KX, Tan MS, Tan CC, Cao XP, Hou XH, Guo QH, Tan L, et al. Comparative safety and effectiveness of cholinesterase inhibitors and memantine for Alzheimer's disease: a network meta-analysis of 41 randomized controlled trials. Alzheimers Res Ther 2018; 10: 126. (Meta-analysis of 41 published randomized controlled trials of drugs for Alzheimer disease concluded that all had beneficial effects on cognition and function but not on neuropsychiatric symptoms, and all had adverse effects but memantine showed “the best profile of acceptability”; no mention of ALT elevations or hepatotoxicity). 30591071
Khoury R, Rajamanickam J, Grossberg GT. An update on the safety of current therapies for Alzheimer's disease: focus on rivastigmine. Ther Adv Drug Saf 2018; 9: 171-8. (Review of the safety of Alzheimer disease agents discusses gastrointestinal adverse events, cardiac side effects, skin reactions [to transdermal formulations] and neuropsychiatric effects, but not hepatic adverse events). 29492246
Arai H, Hashimoto N, Sumitomo K, Takase T, Ishii M. Disease state changes and safety of long-term donepezil hydrochloride administration in patients with Alzheimer's disease: Japan-Great Outcome of Long-term trial with Donepezil (J-GOLD). Psychogeriatrics 2018; 18: 402-11. (Among more than 10,000 Japanese patients with Alzheimer disease treated with donepezil for 48 months, adverse events included anorexia, nausea, diarrhea, agitation, anger, dizziness, delusions, insomnia and restlessness, but there were no major safety problems; hepatic adverse events were not mentioned). 29993162
Matsunaga S, Kishi T, Nomura I, Sakuma K, Okuya M, Ikuta T, Iwata N. The efficacy and safety of memantine for the treatment of Alzheimer's disease. Expert Opin Drug Saf 2018; 17: 1053-61. (Review of the literature on efficacy and safety of memantine concluded that it improves cognitive function and behavioral disturbances and is well tolerated, most common adverse events being somnolence and weight gain; does not discuss ALT elevations or hepatotoxicity, but mentions that hepatitis is listed as an adverse event in the product label). 30222469
Bhattacharjee S, Patanwala AE, Lo-Ciganic WH, Malone DC, Lee JK, Knapp SM, Warholak T, Burke WJ. Alzheimer's disease medication and risk of all-cause mortality and all-cause hospitalization: A retrospective cohort study. Alzheimers Dement (N Y) 2019; 5: 294-302. (Among more than 20,000 Medicare beneficiaries receiving Alzheimer disease drugs, overall survival was better for those on donepezil than memantine or rivastigmine; no mention of serious hepatic adverse events or liver related deaths). 31338414
Hong YJ, Han HJ, Youn YC, Park KW, Yang DW, Kim S, Kim HJ, et al.; ODESA study (Optimal Dose Escalation Strategy to Successful Achievement of High Dose Donepezil 23 mg). Safety and tolerability of donepezil 23 mg with or without intermediate dose titration in patients with Alzheimer's disease taking donepezil 10 mg: a multicenter, randomized, open-label, parallel-design, three-arm, prospective trial. Alzheimers Res Ther 2019; 11: 37. (Among 160 patients with Alzheimer disease receiving donepezil and undergoing dose escalation from 10 to 23 mg daily, there were few gastrointestinal side effects and lower rates of nausea and dizziness in those with an initial titration period to the higher dose; no mention of ALT elevations or hepatotoxicity). 31039806
Shumar J, Ordway S, Junga Z, Sadowski B, Torres D. Memantine-induced liver injury with probable causality as assessed using the Roussel Uclaf Causality Assessment Method (RUCAM). ACG Case Rep J 2019; 6: e00184. (An 86 year old man with Alzheimer disease was found to have abnormal liver tests without symptoms or jaundice, 2 months after adding memantine to his usual medications [ALT 439 U/L, Alk P 169 U/L, bilirubin 0.9 mg/dL], resolving within 6 months of stopping memantine only). 31737715
Chang CC, Peng GS, Lai TJ, Li CH, Liu CK. A 48-week, multicenter, open-label, observational study evaluating oral rivastigmine in patients with mild-to-moderate Alzheimer's disease in Taiwan. Adv Ther 2019; 36: 1455-64. (Among 151 Taiwanese patients with Alzheimer disease treated with rivastigmine, common side effects were dizziness [13%] and nausea [9%], and there were “no new or unexpected” adverse events and no mention of ALT elevations or hepatotoxicity). 30953330
Carney G, Bassett K, Wright JM, Maclure M, McGuire N, Dormuth CR. Comparison of cholinesterase inhibitor safety in real-world practice. Alzheimers Dement (N Y) 2019; 5: 732-9. (Among 29,047 Canadian patients with Alzheimer disease who initiated anticholinesterase therapy between 2007 and 2016, all-cause mortality and serious cardiovascular event rates were lower in those receiving galantamine than those on donepezil; no mention of hepatic adverse events or liver related deaths). 31921965
Matsunaga S, Fujishiro H, Takechi H. Efficacy and safety of cholinesterase inhibitors for mild cognitive impairment: a systematic review and meta-analysis. J Alzheimers Dis 2019; 71: 513-23. (Systematic review of 14 randomized controlled trials of anticholinesterase drugs in Alzheimer disease concluded that the agents had slight efficacy in ameliorating symptoms but a moderate rate of discontinuation because of adverse events such as abnormal dreams, dizziness, headache, insomnia, diarrhea, muscle cramps, nausea and weight loss; no mention of discontinuations because of ALT elevations or hepatotoxicity). 31424411
Li DD, Zhang YH, Zhang W, Zhao P. Meta-analysis of randomized controlled trials on the efficacy and safety of donepezil, galantamine, rivastigmine, and memantine for the treatment of Alzheimer's disease. Front Neurosci 2019; 13: 472. (Meta-analysis of 36 controlled trials of drugs for Alzheimer disease focusing upon relative efficacy and rates of discontinuation in comparison to placebo). 31156366
Wessels AM, Tariot PN, Zimmer JA, Selzler KJ, Bragg SM, Andersen SW, Landry J, et al. Efficacy and safety of lanabecestat for treatment of early and mild Alzheimer disease: The AMARANTH and DAYBREAK-ALZ Randomized Clinical Trials. JAMA Neurol 2020; 77(2): 199-209. Erratum in: JAMA Neurol 2020; 77(9): 1179. (In a phase 3 trial of 2218 patients with early Alzheimer disease treated with lanabecestat [20 or 50 mg] or placebo daily, the study was discontinued early because of futility while adverse events included psychiatric symptoms, weight loss and hair color changes and “no change in pattern of potentially clinically significant…laboratory values… was observed”). 31764959
Egan MF, Kost J, Voss T, Mukai Y, Aisen PS, Cummings JL, Tariot PN, et al. Randomized trial of verubecestat for prodromal Alzheimer's disease. N Engl J Med 2019; 380: 1408-20. (Among 1454 patients with prodromal Alzheimer disease treated with verubecestat [12 or 40 mg] or placebo once daily for up to 48 months, cognitive function and daily functional status appeared to worsen with therapy while ALT elevations above 3 times ULN arose in 0.8% to 1.1% of verubecestat- vs 1.1% of placebo-recipients). 30970186
Egan MF, Mukai Y, Voss T, Kost J, Stone J, Furtek C, Mahoney E, et al. Further analyses of the safety of verubecestat in the phase 3 EPOCH trial of mild-to-moderate Alzheimer's disease. Alzheimers Res Ther 2019; 11: 68. (Among 1454 patients with mild-to-moderate Alzheimer disease treated with verubecestat [12 or 40 mg] or placebo daily for up to 78 weeks, further analysis of safety showed no serious hepatic adverse events and ALT elevations were similar in frequency in all groups and ALT elevations with hyperbilirubinemia arising in 0.3% of verubecestat treated patients and 0.2% of placebo recipients). 31387606
Henley D, Raghavan N, Sperling R, Aisen P, Raman R, Romano G. Preliminary results of a trial of atabecestat in preclinical Alzheimer's disease. N Engl J Med 2019; 380: 1483-5. (Among 557 patients with “preclinical” Alzheimer disease treated with atabecestat [5 or 25 mg] or placebo once daily for up to 18 months, hepatic related adverse events led to an early discontinuation of the trial, although the details were not provided). 30970197